# Dalfampridine

## OVERVIEW

### Introduction

Dalfampridine is a pyrimidine analogue used in the treatment of relapsing multiple sclerosis. Dalfampridine has had limited clinical use, but has not been linked to serum enzyme elevations during treatment nor to instances of clinically apparent liver injury with jaundice.

### Background

Dalfampridine (dal fam' pri deen) is a pyrimidine analogue (4-aminopyridine) and potassium channel blocker that is used to improve mobility and walking speed in patients with multiple sclerosis. Dalfampridine appears to act by prolonging neuronal action potentials and thus improving conduction in demyelinated nerve fibers. Multiple clinical studies have demonstrated that dalfampridine (previously known as 4-aminopyridine) has a rapid onset of action increasing motor strength and mobility in 25% to 40% of patients with multiple sclerosis as well as other neuromuscular conditions. In clinical trials, the effect of dalfampridine has been sustained with long term use. It has no effect on the course of underlying disease in preventing relapses or slowing progression of disability. Dalfampridine was approved for use in the United States in 2010 and current indications are for symptomatic treatment of motor weakness in relapsing multiple sclerosis. Dalfampridine is available in tablets of 10 mg generically and under the brand name Ampyra. Fampridine, the active product of dalfampridine, is available outside the United States, but is essentially the same drug and should not be taken in combination with dalfampridine. The typical dose of dalfampridine in adults is 10 mg twice daily. Side effects may include insomnia, dizziness, headache, nausea, dyspepsia, constipation, fatigue, back pain, paresthesia, ataxia, and relapse of multiple sclerosis. Uncommon, but serious side effects include hypersensitivity reactions, seizures, delirium and stupor. 4-aminopyridine is also used as a bird repellant, an avicide and well known neurotoxin. Overdoses in humans can cause seizures, stupor, coma and death.

### Hepatotoxicity

Dalfampridine has been associated with infrequent serum aminotransferase elevations during therapy and has not been convincingly linked to instances of clinically apparent liver injury. In analyses of safety of dalfampridine in pre-registration controlled trials with 1922 patients with multiple sclerosis, there were no reports of hepatic injury or laboratory evidence of a hepatotoxicity signal. Among a few instances of clinically apparent liver injury in patients receiving dalfampridine have appeared in the published literature, in each instance attribution to dalfampridine was not convincing. In large registries of patients taking dalfampridine, hepatic adverse events have not been reported. Finally, in large prospectively collected registries of drug-induced liver injury, there have been no cases attributed to dalfampridine or other formulations of fampridine.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The possible mechanisms by which dalfampridine could be hepatotoxic are not clear. Dalfampridine is eliminated largely unchanged in the urine and appears to have little hepatic metabolism.

Drug Class: Multiple Sclerosis Agents (Symptomatic Therapies)

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Dalfampridine – Generic, Ampyra®

DRUG CLASS

Multiple Sclerosis Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Dalfampridine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Dalfampridine | 504-24-5 | C5-H6-N2

## ANNOTATED BIBLIOGRAPHY

References updated: 01 December 2025

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 731-4. (Expert review of hepatotoxicity published in 1999 before the availability of dalfampridine).
Larrey D, Ripault M-P. Anxiolytic agents. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 455-6. (Review of hepatotoxicity of hypnotics and sedatives, does not discuss dalfampridine).
Krensky AM, Azzi JR, Hafler DA. Immunotherapy for multiple sclerosis. Immunosuppressants and tolerogens. In, Brunton LL, Hilal-Dandan, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 649-652. (Textbook of pharmacology and therapeutics; dalfampridine is not discussed).
Davis FA, Stefoski D, Rush J. Orally administered 4-aminopyridine improves clinical signs in multiple sclerosis. Ann Neurol 1990; 27: 186-92. (Single dose study of 10 or 25 mg of oral dalfampridine or placebo in 20 subjects with multiple sclerosis showed rapid but reversible improvement in motor function in most patients given active drug, without serious adverse effects and no improvement in placebo recipients). 2317014
Stefoski D, Davis FA, Fitzsimmons WE, Luskin SS, Rush J, Parkhurst GW. 4-Aminopyridine in multiple sclerosis: prolonged administration. Neurology 1991; 41: 1344-8. (Prolonged administration of oral dalfampridine or placebo 26 subjects with multiple sclerosis in different dose regimens for 5 days showed motor and visual improvement with active drug and little change with placebo; no serious adverse events occurred). 1891078
van Diemen HA, Polman CH, van Dongen TM, van Loenen AC, Nauta JJ, Taphoorn MJ, van Walbeek HK, et al. The effect of 4-aminopyridine on clinical signs in multiple sclerosis: a randomized, placebo-controlled, double-blind, cross-over study. Ann Neurol 1992; 32: 123-30. (Among 70 patients with multiple sclerosis treated with dalfampridine or placebo for 12 weeks and 63 crossed over to opposite treatment, side effects included paresthesia, dizziness, ataxia, nausea and headache, without any changes in laboratory test results). 1510353
Bever CT Jr, Anderson PA, Leslie J, Panitch HS, Dhib-Jalbut S, Khan OA, Milo R, et al. Treatment with oral 3,4 diaminopyridine improves leg strength in multiple sclerosis patients: results of a randomized, double-blind, placebo-controlled, crossover trial. Neurology 1996; 47: 1457-62. (Among 36 patients with multiple sclerosis treated with dalfampridine or placebo for 16 weeks, neurologic improvements occurred in most patients on active drug, but side effects were frequent, 8 patients withdrew, 3 had episodes of confusion and one had seizures). 8960727
Polman CH, Bertelsmann FW, van Loenen AC, Koetsier JC. 4-aminopyridine in the treatment of patients with multiple sclerosis. Long-term efficacy and safety. Arch Neurol 1994; 51: 292-6. (Among 23 patients with multiple sclerosis treated with dalfampridine for more than 6 months, one 60 year old woman developed jaundice 6 months after starting dalfampridine but 6 weeks after receiving high doses of intravenous methylprednisolone [bilirubin 2.0, ALT 819 U/L, GGT 199 U/L], which resolved uneventfully within 3 months). 8129642
Johnson NC, Morgan MW. An unusual case of 4-aminopyridine toxicity. J Emerg Med 2006; 30: 175-7. (56 year old man with diabetic neuropathy rubbed dalfampridine on a sore tooth and rapidly developed delirium and coma, atrial fibrillation and cardiac arrhythmias, which resolved after 3 to 4 days). 16567254
Burton JM, Bell CM, Walker SE, O'Connor PW. 4-aminopyridine toxicity with unintentional overdose in four patients with multiple sclerosis. Neurology 2008; 71: 1833-4. (3 patients with multiple sclerosis being treated with dalfampridine developed seizures and status epilepticus hours after starting a new, locally compounded prescription, which later was found to have 90-126 mg per tablet instead of the intended 10 mg). 19029525
Goodman AD, Brown TR, Krupp LB, Schapiro RT, Schwid SR, Cohen R, Marinucci LN, Blight AR; Fampridine MS-F203 Investigators. Sustained-release oral fampridine in multiple sclerosis: a randomised, double-blind, controlled trial. Lancet 2009; 373 (9665): 732-8. (In a placebo controlled trial of 301 patients with multiple sclerosis treated for 14 weeks, walking time improved significantly in 35% of dalfampridine vs 5% of placebo recipients, and "some patients had clinically significant changes during treatment for laboratory values... but there were no clear trends within or differences between treatment groups"). 19249634
Traynor K. Dalfampridine approved for MS. Am J Health Syst Pharm 2010; 67: 335. (News report; in clinical trials conducted in 540 patients with multiple sclerosis, dalfampridine was found to increase walking speed, while the most common side effects were urinary tract infections, dizziness, gastrointestinal upset, headache, insomnia, stuffy nose, throat pain and weakness; no mention of ALT elevations or hepatotoxicity). 20172978
Goodman AD, Brown TR, Edwards KR, Krupp LB, Schapiro RT, Cohen R, Marinucci LN, Blight AR; MSF204 Investigators. A phase 3 trial of extended release oral dalfampridine in multiple sclerosis. Ann Neurol 2010; 68: 494-502. (Among 239 patients with multiple sclerosis treated with dalfampridine or placebo for 9 weeks, the average improvement in walking time with therapy was 25% and "there were no notable differences between treatment groups with respect to laboratory values"). 20976768
Dalfampridine (Ampyra) for MS. Med Lett Drugs Ther 2010; 52 (1347): 73-4. (Concise review of the mechanism of action, efficacy, safety and costs of dalfampridine shortly after its approval in the US, mentions common side effects were urinary tract infection, insomnia, dizziness, head nausea, fatigue, back pain and ataxia; no mention of ALT elevations or hepatotoxicity). 20847716
Cornblath DR, Bienen EJ, Blight AR. The safety profile of dalfampridine extended release in multiple sclerosis clinical trials. Clin Ther 2012; 34: 1056-69. (Review of the literature on the safety of dalfampridine focused on common side effect symptoms; "although a few clinically significant changes in...laboratory values were observed across the studies, there did not appear to be any clinically significant trends within or differences among treatment groups..."). 22497693
King AM, Menke NB, Katz KD, Pizon AF. 4-aminopyridine toxicity: a case report and review of the literature. J Med Toxicol 2012; 8: 314-21. (37 year old man with progressive multiple sclerosis developed diaphoresis, delirium, agitation and choreathetoid movements after a suspected overdose of dalfampridine requiring intubation, but ultimately resolving after 5-6 days; no mention of liver test abnormalities). 22782458
Prugger M, Berger T. Assessing the long-term clinical benefit of prolonged-release fampridine tablets in a real-world setting: a review of 67 cases. Patient Relat Outcome Meas 2013; 4: 75-85. (Among 67 patients with multiple sclerosis treated with dalfampridine and followed for up to 6 months, adverse events leading to discontinuation included nausea and insomnia; no mention of ALT elevations or hepatotoxicity). 24187513
McLean MK, Khan S. A review of 29 incidents involving 4-aminopyridine in non-target species reported to the ASPCA Animal Poison Control Center. J Med Toxicol 2013; 9: 418-21. (4-aminopyrine is a bird poison used for bird control in airports and feedlots, but can also poison mammals; report of 29 cases of toxicosis from the poison, mostly in dogs, causing neurologic symptoms and at least 1 death). 24129835
Jara M, Barker G, Henney HR 3rd. Dalfampridine extended release tablets: 1 year of postmarketing safety experience in the US. Neuropsychiatr Dis Treat 2013; 9: 365-70. (Summary of spontaneous adverse event reports attributed to dalfampridine during the first year of marketing included 11,549 adverse events in ~46,000 patients, mostly dizziness, insomnia, ataxia, headache and nausea, but also 85 seizures, 1 case of hepatitis and 1 of hepatic failure; but no details given). 23662056
Ruck T, Bittner S, Simon OJ, Gö K, Wiendl H, Schilling M, Meuth SG. Long-term effects of dalfampridine in patients with multiple sclerosis. J Neurol Sci 2014; 337: 18-24. (Among 30 patients with multiple sclerosis treated with dalfampridine for 9-12 months, beneficial effects on mobility and fatigue were maintained and no new adverse side effects were identified). 24290498
Yapundich R, Applebee A, Bethoux F, Goldman MD, Hutton GJ, Mass M, Pardo G, et al. Evaluation of dalfampridine extended release 5 and 10 mg in multiple sclerosis: a randomized controlled trial. Int J MS Care 2015; 17: 138-45. (430 patients with multiple sclerosis treated with dalfampridine [5 or 10 mg twice daily] or placebo for 4 weeks showed slight improvements in walking speed during dalfampridine therapy compared with placebo, but only with the higher dose; no mention of ALT elevations or hepatotoxicity). 26052259
Goodman AD, Bethoux F, Brown TR, Schapiro RT, Cohen R, Marinucci LN, Henney HR 3rd, et al; MS-F203, MS-F204, and Extension Study Investigators. Long-term safety and efficacy of dalfampridine for walking impairment in patients with multiple sclerosis: Results of open-label extensions of two Phase 3 clinical trials. Mult Scler 2015;21:1322-31. (Among 483 patients with multiple sclerosis participating in controlled trials of dalfampridine who were enrolled in long term extension studies for up to 5 years, improvements in walking speed tended to decrease over time, and "no new safety signals emerged and no patterns were observed in regard to laboratory findings"). 25583832
Goodman AD, Brown TR, Schapiro RT, Klingler M, Cohen R, Blight AR. A pooled analysis of two phase 3 clinical trials of dalfampridine in patients with multiple sclerosis. Int J MS Care 2014; 16: 153-60. (Among 540 patients with multiple sclerosis enrolled in two placebo controlled trials of dalfampridine, "no notable patterns were observed between treatment groups with respect to laboratory values"). 25337058
Ballesta Méez M, van Pesch V, Capron A, Hantson P. Prolonged toxic encephalopathy following accidental 4-aminopyridine overdose. Case Rep Neurol Med 2014; 2014: 237064. (58 year old woman with multiple sclerosis developed abdominal pain, stupor and generalized seizures a few minutes after taking 80 mg of dalfampridine [due to an incorrect formulation], ultimately requiring intubation and prolonged ICU stay with prolonged hospitalization and residual neurologic defects). 24822136
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 7 [0.8%] were attributed to interferon beta, but none were linked to dalfampridine or other drugs for multiple sclerosis). 25754159
Hupperts R, Lycke J, Short C, Gasperini C, McNeill M, Medori R, Tofil-Kaluza A, et al. Prolonged-release fampridine and walking and balance in MS: randomised controlled MOBILE trial. Mult Scler. 2016;22:212-21..25921050
(Among 134 patients with multiple sclerosis and mobility impairment treated with a prolonged release fampridine [similar to extended release dalfampridine] go mg given twice daily or placebo for 24 weeks, symptom scores for mobility and balance improved more with drug than placebo, and adverse event rates were similar [77% vs 75%], ALT and other blood test results were not mentioned)
Fragoso YD, Adoni T, Alves-Leon SV, Apostolos-Pereira SL, Barreira AA, Brooks JB, Claudino R, et al. Real-life experience with fampridine (Fampyra®) for patients with multiple sclerosis and gait disorders. NeuroRehabilitation. 2016;39:301-4.. (Among 89 adult Brazilian patients with multiple sclerosis treated with fampridine [10 mg twice daily], ambulation improved in 70% and side effects included single cases of somnolence, insomnia, nausea, and 2 cases of seizures; no mention of ALT elevations or hepatotoxicity). 27372365
Page SJ, Kasner SE, Bockbrader M, Goldstein M, Finklestein SP, Ning M, El-Feky WH, et al.; all of the investigators involved in the MILESTONE study. A double-blind, randomized, controlled study of two dose strengths of dalfampridine extended release on walking deficits in ischemic stroke. Restor Neurol Neurosci. 2020;38:301-309.. (Among 377 patients with walking deficits after an ischemic stroke who were treated with dalfampridine [7.5 mg or 10 mg] or placebo twice daily for 12 weeks, 2 minute walk distance improvements were similar in all 3 groups and “no new safety signal’ and “no hepatic abnormalities were observed”). 32651338
Castelnovo G, Gerlach O, Freedman MS, Bergmann A, Sinay V, Castillo-Triviño T, Kong G, et al. Safety, patient-reported well-being, and physician-reported assessment of walking ability in patients with multiple sclerosis for prolonged-release fampridine treatment in routine clinical practice: results of the LIBERATE Study. CNS Drugs. 2021;35:1009-1022.. (Among 4646 patients with multiple sclerosis started on prolonged-release fampridine and enrolled in an observation study at 201 sites in 13 countries, the most common adverse events reported were dizziness [2.9%], insomnia [2.1%], headache [1.7%], nausea [1.6%], vertigo [1.4%], and paresthesia [1.1%], and less frequent events included seizures [0.7%], anxiety, suicide attempts, and hypersensitivity reactions; no mention of ALT elevations or hepatic adverse events). 34322853
Xiong R, Lei J, Pan S, Zhang H, Tong Y, Wu W, Huang Y, et al. Post-marketing safety surveillance of dalfampridine for multiple sclerosis using FDA adverse event reporting system. Front Pharmacol. 2023;14:1226086.. (Among 44,092 spontaneous adverse event reports [including 1247 deaths] attributed to dalfampridine made to the FDA’s Adverse Event Reporting System [FAERS] between 2010 and 2022, neither ALT elevations nor hepatic specific events were mentioned). 37781705
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, one case was attributed to fingolimod and one to natalizumab, but none to dalfampridine or other agents used to treat multiple sclerosis: personal communication). 38992407

## OTHER REFERENCE LINKS

1. Recent References on Dalfampridine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Dalfampridine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Dalfampridine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Dalfampridine)